# Futibatinib

## OVERVIEW

### Introduction

Futibatinib is a FGF receptor 2 kinase inhibitor that is used in the treatment of unresectable, locally advanced or metastatic intrahepatic cholangiocarcinoma. Futibatinib is associated with transient and usually mild elevations in serum aminotransferase during therapy, but has not been convincingly linked to cases of clinically apparent liver injury.

### Background

Futibatinib (fue” ti ba’ ti nib) is an orally available, specific inhibitor of the fibroblast growth factor (FGF) receptor 1, 2 and 3 kinases that is used in the therapy of advanced or metastatic cholangiocarcinoma. Aberrant FGF receptor signaling is associated with several cancer types in which amplifications, translocations, fusings, and other activating point mutations of FGF receptors are found. These FGF receptor mutations and fusions cause uncontrolled cell growth and tumorigenesis, and are particularly common in intrahepatic cholangiocarcinomas. In cell culture and animal models, Inhibition of the mutant overexpressed receptor causes regression of cell proliferation and promotes cell death. Open label trials of futibatinib in patients with advanced or metastatic cholangiocarcinoma demonstrated a favorable overall durable response rate which led to its accelerated approval for use in the United States in 2022. Current indications are limited to adults with previously treated, unresectable, locally advanced, or metastatic intrahepatic cholangiocarcinoma with FGF receptor 2 gene fusions or other rearrangements. It is under continuing evaluation for its long term safety and efficacy as therapy of cholangiocarcinoma and for its possible efficacy in other forms of cancer associated with FGF receptor gene mutations. Futibatinib is available in tablets of 4 mg under the brand name Lytgobi. The recommended dose is 20 mg (5 tablets) once daily indefinitely or until there is disease progression or unacceptable toxicity. Common side effects include hyperphosphatemia (an effect of inhibition of FGF signaling) as well as symptoms of fatigue, nausea, diarrhea, anorexia, abdominal pain, anemia, thrombocytopenia, musculoskeletal pain, alopecia, nail toxicity, and hand-foot syndrome. Severe adverse events include neutropenic fever, sepsis, ocular toxicity, severe hyperphosphatemia and embryo-fetal toxicity.

### Hepatotoxicity

In the open label clinical trials of futibatinib, adverse events were common and led to dose interruptions in 66%, dose reductions in 58%, and drug discontinuation in 5% of patients but only a small proportion of these were due to serum aminotransferase elevations. In preregistration trials in 103 patients with cholangiocarcinoma, ALT elevations arose in 50% and to above 5 times ULN in 7%. The elevations were typically self-limited and resolved rapidly with or without dose adjustments. No patients developed clinically apparent liver injury or jaundice. Publications on the efficacy and safety of futibatinib rarely mentioned serum ALT elevations or hepatotoxicity. Since its approval, there have been no reports clinically apparent liver injury attributed to futibatinib. However, the total clinical experience with its use has been limited and the frequency of serum aminotransferase elevations during therapy suggest that clinically significant liver injury may occur.

Likelihood score: E* (unproven, but possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of serum enzyme elevations or liver injury from futibatinib therapy are not known. Some of the adverse effects of futibatinib are due to its effects on FGF signaling (hyperphosphatemia) and others may be due to off-target effects on other kinases (such as RET). Futibatinib is metabolized in the liver largely through the CYP 3A4 pathway and liver injury might be caused by production of a toxic or immunogenic intermediate. Because it is a substrate for CYP 3A4, futibatinib is susceptible to drug-drug interactions with agents that inhibit or induce this specific hepatic microsomal activity.

### Outcome and Management

Futibatinib is associated with a moderate rate of serum aminotransferase elevations that are generally transient and not associated with symptoms or jaundice. While regular monitoring of liver tests is not recommended for futibatinib therapy, elevations if confirmed should lead to follow up monitoring. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) or any elevations accompanied by jaundice or symptoms should lead to dose reduction or temporary cessation until they resolve or another cause is identified. There is no evidence to suggest a cross reactivity in risk for adverse events, hypersensitivity or hepatic injury between futibatinib and other protein kinase inhibitors including other FGF receptor inhibitors such as erdafitinib, infigratinib and pemigatinib.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other FGF Receptor Kinase Inhibitors: Erdafitinib, Infigratinib, Pemigatinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Futibatinib – Lytgobi®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Futibatinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Futibatinib | 1448169-71-8 | C22-H22-N6-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 30 November 2022

Abbreviations: FGF, fibroblast growth factor; HER2, human epidermal growth factor 2 receptor.

Zimmerman HJ. Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase inhibitors such as futibatinib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not futibatinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2022/214801Orig1s000MultidisciplineR.pdf (FDA website with product labels, letters and multidisciplinary review of the applications for futibatinib mentions that adverse events were common, led to drug discontinuation in 5% [none liver related], interruptions in 66% [10% liver related] and dose reductions in 58% [5% liver related], and ALT elevations arose in 50% of 103 treated subjects which were above 5 times ULN in 7%, but all were self-limited and there were no serious hepatic adverse events or instances of clinically apparent liver injury with jaundice).
Spraggs CF, Xu CF, Hunt CM. (2013). Genetic characterization to improve interpretation and clinical management of hepatotoxicity caused by tyrosine kinase inhibitors. Pharmacogenomics. (Review of genetic associations of serum ALT and bilirubin elevations during therapy with tyrosine kinase inhibitors focusing on lapatinib and pazopanib; futibatinib is not discussed).
Shah RR, Morganroth J, Shah DR. (2013). Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013, before the availability of futibatinib which is not discussed).
Arai Y, Totoki Y, Hosoda F, Shirota T, Hama N, Nakamura H, Ojima H, et al. (2014). Fibroblast growth factor receptor tyrosine kinase fusions define a unique molecular subtype of cholangiocarcinoma. Hepatology. (Whole transcriptome sequencing from 8 cholangiocarcinomas identified two FGF receptor fusion genes and screening of different human cancer tissues found FGF receptor fusions in 9 of 102 cholangiocarcinomas [all intrahepatic] but only 1 of 149 colorectal, 1 of 96 hepatocellular, and none of 212 gastric cancers; expression of the fusion kinases in cell cultures led to anchorage independent growth and tumorigenesis when implanted in mice).
Bahleda R, Meric-Bernstam F, Goyal L, Tran B, He Y, Yamamiya I, Benhadji KA, et al. (2020). Phase I, first-in-human study of futibatinib, a highly selective, irreversible FGFR1-4 inhibitor in patients with advanced solid tumors. Ann Oncol. (Among 86 patients with various solid tumors harboring aberrations in FGF and FGF receptor genes treated with different futibatinib dose regimens, partial responses arose in patients with cholangiocarcinoma, glioblastoma, colorectal and breast cancer, and adverse events were frequent including hyperphosphatemia [59%], constipation [34%], diarrhea [37%], nausea [29%], and ALT elevations [19%], but there were no hepatic severe adverse events or treatment related deaths).
Krook MA, Reeser JW, Ernst G, Barker H, Wilberding M, Li G, Chen HZ, et al. (2021). Fibroblast growth factor receptors in cancer: genetic alterations, diagnostics, therapeutic targets and mechanisms of resistance. Br J Cancer. (Review of the association of FGF receptors and cancer chemotherapeutic agents, activating mutations being found in 5-10% of cancers overall, but in 10% to 20% of cholangiocarcinomas).
Rizzo A, Ricci AD, Brandi G. (2021). Futibatinib, an investigational agent for the treatment of intrahepatic cholangiocarcinoma: evidence to date and future perspectives. Expert Opin Investig Drugs. (Review of futibatinib a kinase inhibitor of FGF receptors which are commonly aberrant in cholangiocarcinoma [6-25%] and thus a strong candidate for FGF receptor kinase inhibitor therapy).
Meric-Bernstam F, Bahleda R, Hierro C, Sanson M, Bridgewater J, Arkenau HT, Tran B, et al. (2022). Futibatinib, an irreversible FGFR1-4 inhibitor, in patients with advanced solid tumors harboring FGF/FGFR aberrations: a phase I dose-expansion study. Cancer Discov. (Among 197 adults with various advanced solid tumors treated with futibatinib, the overall response rate was 13.7% with partial responses in various cancers including cholangiocarcinoma, gastric, urothelial, CNS, head-neck and breast cancer and the safety profile was “manageable” with ALT elevations in 64% [10% above 5 times ULN], hyperphosphatemia in 81%, diarrhea in 33%, constipation in 32%, nausea in 28%, fatigue in 25%, and hand-foot syndrome in 13%).

## OTHER REFERENCE LINKS

1 Recent References on Futibatinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Futibatinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Futibatinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Futibatinib)